# Emergency Contraceptive Agents

## OVERVIEW

Oral means of emergency contraception, colloquially known as “morning after” pills, are used to prevent unwanted pregnancy after unprotected intercourse or suspected contraceptive failure. Two commonly used forms of emergency contraception are levonorgestrel and ulipristal acetate. Both can be administered as a single oral dose, ulipristal within 5 days and levonorgestrel within 2 days of the unprotected intercourse. Both have been shown to be safe and effective, rates of subsequent pregnancy being 0.6% to 3% compared to an expected rate of 5% to 6%. Levonorgestrel is available over-the-counter whereas ulipristal, at least in the United States, is available by prescription only. Neither approach to emergency contraception has been linked to serum enzyme elevations or to clinically apparent liver injury. However, ulipristal when given in daily doses in 3 month courses as therapy for symptomatic uterine fibroids has been linked to several instances of clinically apparent liver injury, some of which have been severe and even fatal.

### Levonorgestrel

#### Introduction

Levonorgestrel is a synthetic progesterone that is used for emergency contraception. Levonorgestrel is also used alone and in combination with estrogens in conventional oral contraceptives. Use of levonorgestrel for emergency contraception has not been associated with serum enzyme elevations or clinically apparent liver injury with jaundice.

#### Background

Levonorgestrel (lee" voe nor jes' trel) is a synthetic progesterone that is used as a single or as two oral doses within 2 days of unprotected intercourse or contraceptive failure as a means of emergency contraception. Levonorgestrel acts as an agonist of the progesterone receptor and is believed to act by preventing ovulation. In both animal models and in human trials, levonorgestrel appears to be effective only when given before the luteinizing hormone (LH) surge that precedes ovulation and has little or no effect on fertilization or implantation. In large prospective studies, levonorgestrel given in a single or as two doses 12 hours apart lowered the rate of unwanted pregnancies by 50% to 90% of the expected rate, and the effect was seen for as long as 48 hours after unprotected intercourse or suspected contraceptive failure. The overall failure rates of levonorgestrel have ranged from 0.6% to 3.1%, the expected rates being 5% to 6%. Levonorgestrel was approved in the United States for use as emergency contraception in 1982 and remains available generically and over-the-counter as tablets of 0.75 and 1.5 mg. The recommended regimen is a total dose of 1.5 mg within 72 hours of the unprotected intercourse or suspected contraceptive failure, given either as a single or split (12 hours apart) oral dose. Side effects are generally mild-to-moderate in severity and can include headache, nausea, abdominal pain, dysmenorrhea, breast tenderness, fatigue, and dizziness.

Levonorgestrel is also used as a progestin in conventional oral contraceptives, administered alone or in combination with estrogens. The safety and hepatotoxicity of oral contraceptives are discussed separately in LiverTox in sections Estrogens and Oral Contraceptives, and Progesterone and the Progestins.

#### Hepatotoxicity

In large prospective trials of levonorgestrel as emergency contraception that included laboratory testing, mean serum ALT and AST levels remained unchanged and only rare, minor elevations of serum enzymes occurred that were invariably transient, not accompanied by jaundice or symptoms and not considered related to the emergency contraception. Despite widescale use of levonorgestrel for several decades, there have been no published reports of hepatotoxicity attributable to its use as emergency contraception.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

#### Mechanism of Injury

The mechanism by which levonorgestrel used for emergency contraception might cause liver injury is uncertain. It is typically given in one or two low doses, the total amount being only 1.5 mg. Levonorgestrel is metabolized in the liver predominantly via CYP 3A4 and is susceptible to drug-drug interactions with potent inducers or inhibitors of the drug-metabolizing enzyme. Levonorgestrel is a progesterone, but has not been linked to the cholestatic forms of injury associated with convention oral contraceptives that contain progesterone alone or combined with estrogens.

### Ulipristal

#### Introduction

Ulipristal acetate is a selective progesterone receptor modulator that is used in a single oral dose for emergency contraception. Use of ulipristal has not been associated with serum enzyme elevations or with clinically apparent liver injury with jaundice.

#### Background

Ulipristal (ue" le pris' tal) is a selective progesterone receptor modulator that is used in a single oral dose within 5 days of unprotected intercourse or suspected contraceptive failure as a means of emergency contraception. Ulipristal acts as a mixed, partial agonist and antagonist of the progesterone receptor and is believed to act by preventing both ovulation and fertilization. Unlike levonorgestrel, ulipristal can be used up to 5 days after the episode of unprotected intercourse, being effective both before and during the early phase of the luteinizing hormone (LH) surge. Ulipristal has minor effects on the uterine epithelium that may inhibit implantation. In large prospective studies, ulipristal was found to lower the rate of unwanted pregnancies by 50% to 90% of the expected rate when given up to 5 days after unprotected intercourse or suspected contraceptive failure. The overall failure rate of emergency contraception with ulipristal has ranged from 0.9% to 2.1%, the expected rates being in the range of 5% to 6%. Ulipristal was approved in the United States for use in emergency contraception in 2010 and remains available by prescription as tablets of 30 mg under the brand name Ella. The recommended regimen is a single oral dose of 30 mg within 5 days of the unprotected intercourse or suspected contraceptive failure. Side effects are generally mild-to-moderate in severity and can include headache, nausea, abdominal pain, dysmenorrhea, breast tenderness, fatigue, and dizziness.

Ulipristal has also been evaluated as nonsurgical therapy of uterine fibroids. When given in daily doses of 5 to 10 mg for 2 to 3 months, ulipristal was found to decrease uterine bleeding and total fibroid volume. Side effects included amenorrhea, headaches, hot flushes, nausea, vomiting, abdominal cramps and menorrhagia. Ulipristal was approved for this indication in the European Union, but its use was restricted after several reports of severe liver injury were reported in women being treated for uterine fibroids.

#### Hepatotoxicity

In large prospective trials of ulipristal that included laboratory testing, there were isolated moderate elevations in ALT levels, but all were transient, less than 3 times the upper limit of normal and not accompanied by jaundice or symptoms. Since approval of ulipristal in 2010 there have been no reports of liver injury associated with its use in emergency contraception as a one-time dose.

Likelihood score when used for emergency contraception: E (unlikely cause of clinically apparent liver injury).

Ulipristal has also been used in daily doses of 5 mg in 3 month courses as therapy of uterine fibroids. In preregistration trials, ulipristal when given in doses of 5 mg daily was not associated with serum enzyme elevations or with instances of clinically apparent liver injury. Ulipristal did not receive approval as therapy of uterine fibroids in the United States but was approved for this indication in the European Union in 2012. Subsequently, there have been several reports of severe liver injury, including acute liver failure requiring liver transplantation in women being treated for fibroids. The latency to onset ranged from 1 to 6 months and the clinical presentation was with fatigue and an acute hepatocellular pattern of enzyme elevations followed by jaundice. Several instances of acute liver failure were reported to the European Medicines Agency which conducted a formal review of the hepatotoxicity of ulipristal in 2018, which led to a restriction in its use to moderately-to-severely symptomatic uterine fibroids unresponsive to other therapies. Avoidance of therapy in patients with preexisting liver disease and monthly monitoring for serum enzyme elevations was also recommended, with prompt discontinuation for de novo elevations. Whether prospective monitoring is effective in preventing serious liver injury in women treated with ulipristal is unclear. Similar cases of clinically apparent liver injury have not been reported with the use of ulipristal as an emergency contraceptive agent.

Likelihood score when used in daily doses for uterine fibroids: C (probable cause of clinically apparent liver injury).

#### Mechanism of Injury

The mechanism by which ulipristal might cause liver injury is uncertain. It is typically given as a single dose for emergency contraception, but in daily somewhat low doses for symptomatic uterine fibroids. Ulipristal is metabolized in the liver predominantly via CYP 3A4 and is susceptible to drug-drug interactions with potent inducers or inhibitors of CYP 3A. Ulipristal is a partial progesterone receptor agonist, but has not been linked to the cholestatic forms of injury associated with estrogen and progesterone administration. The hepatocellular injury associated with long term use appears to be idiosyncratic.

Drug Class: Obstetrical and Gynecological Agents, Emergency Contraceptive Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Levonorgestrel – Generic, Plan B®

Ulipristal Acetate – Ella®

DRUG CLASS

Emergency Contraceptive Agents

[underlined: COMPLETE LABELING]

Levonorgestrel (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Levonorgestrel)

Ulipristal Acetate (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=ULIPRISTAL+ACETATE&pagesize=20&page=1)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Levonorgestrel | 797-63-7 | C21-H28-O2
Ulipristal | 159811-51-5 | C28-H35-N-O3
Progesterone | 57-83-0 | C21-H30-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 02 June 2020

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999; does not specifically discuss levonorgestrel or ulipristal).
Chitturi S, Farrell GC. Estrogen receptor antagonists. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal agents; discusses estrogens and progestins, but does not specifically discuss levonorgestrel or ulipristal).
Schimmer BP, Parker KL. Contraception and pharmacotherapy of obstetrical and gynecological disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1833-52. (Textbook of pharmacology and therapeutics).
(2004). Emergency contraception OTC. Med Lett Drugs Ther. (Concise review of the efficacy, safety and costs of the over-the-counter form of Plan B that contains two 0.75 mg tablets of levonorgestrel; mentions side effects of nausea and vomiting, headache, abdominal pain and breast tenderness).
Glasier AF, Cameron ST, Fine PM, Logan SJ, Casale W, Van Horn J, Sogor L, et al. (2010). Ulipristal acetate versus levonorgestrel for emergency contraception: a randomised non-inferiority trial and meta-analysis. Lancet. (Among 1899 women requesting emergency contraception within 5 days of unprotected sexual intercourse who were treated with either ulipristal [30 mg] or levonorgestrel [1.5 mg] and had adequate follow up evaluations, 50 pregnancies occurred and rates were lower with ulipristal [1.8% vs 2.6%] and adverse events were similar in both groups; no mention of ALT elevations or hepatotoxicity).
(2011). Ella: a new emergency contraceptive. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of ulipristal acetate as emergency contraception shortly after its approval for use in the US; mentions its side effects of headache, nausea, abdominal pain, dysmenorrhea, fatigue, and dizziness, but not serious adverse events, ALT elevations or hepatotoxicity).
Snow SE, Melillo SN, Jarvis CI. (2011). Ulipristal acetate for emergency contraception. Ann Pharmacother. (Review of the safety and efficacy of ulipristal for emergency contraception; mentions that common adverse events included headache [17%], breast tenderness [16%], nausea [15%] and abdominal pain [13%], and that severe adverse events were rare and none were considered related to ulipristal).
Chen QJ, Xiang WP, Zhang DK, Wang RP, Luo YF, Kang JZ, Cheng LN. (2011). Efficacy and safety of a levonorgestrel enteric-coated tablet as an over-the-counter drug for emergency contraception: a Phase IV clinical trial. Hum Reprod. (Among 2445 women requesting emergency contraception treated with levonorgestrel within 72 hours of unprotected intercourse, the pregnancy rate was 0.2% and adverse events included nausea, vomiting, vaginal bleeding, headache, and dizziness, but there was no mention of ALT elevations or liver related adverse events).
Cheng L, Che Y, Gülmezoglu AM. (2012). Interventions for emergency contraception. Cochrane Database Syst Rev. (Systematic analysis of 100 randomized controlled trials of emergency contraception with 55,666 women using mifepristone, levonorgestrel, copper intrauterine device placement and ulipristal, reported that all regimens were safe; no mention of ALT elevations or hepatotoxicity).
Donnez J, Tatarchuk TF, Bouchard P, Puscasiu L, Zakharenko NF, Ivanova T, Ugocsai G, et al. (2012). PEARL I Study Group. Ulipristal acetate versus placebo for fibroid treatment before surgery. N Engl J Med. (Among 239 women with symptomatic uterine fibroids and excessive bleeding treated with ulipristal [5 vs 10 mg] or placebo daily for up to 13 weeks before surgery, uterine bleeding and fibroid size decreased with ulipristal and adverse events included amenorrhea [73% and 82% vs 6%], headache and breast pain, but “there was no significant difference among the groups in the incidence of abnormal liver-function tests”).
Richardson AR, Maltz FN. (2012). Ulipristal acetate: review of the efficacy and safety of a newly approved agent for emergency contraception. Clin Ther. (Systematic review of safety and efficacy of emergency contraception using ulipristal or levonorgestrel reported no “clinically significant changes in biochemical parameters”).
(2013). Plan B one-step OTC. Med Lett Drugs Ther. (Concise review of efficacy and safety of single vs two dose levonorgestrel regimens for emergency contraception; mentions common adverse events of headache, abdominal pain and breast tenderness, but does not mention ALT elevations or hepatotoxicity).
Turok DK, Jacobson JC, Dermish AI, Simonsen SE, Gurtcheff S, McFadden M, Murphy PA. (2014). Emergency contraception with a copper IUD or oral levonorgestrel: an observational study of 1-year pregnancy rates. Contraception. (Among 542 women requesting emergency contraception who were treated with oral levonorgestrel or implantation of a copper IUD, the one year pregnancy rates were 12% vs 7% and there were no reports of serious adverse events, ALT elevations or hepatotoxicity).
Levy DP, Jager M, Kapp N, Abitbol JL. (2014). Ulipristal acetate for emergency contraception: postmarketing experience after use by more than 1 million women. Contraception. (A summary of spontaneous reports of adverse events after use of ulipristal for emergency contraception in more than one million women mentions side effects of nausea, headache, abdominal pain, and dizziness, but not ALT elevations or liver related adverse events).
Cleland K, Raymond EG, Westley E, Trussell J. (2014). Emergency contraception review: evidence-based recommendations for clinicians. Clin Obstet Gynecol. (Review of emergency contraception mentions that the failure rates of ulipristal range from 0.9-2.1% and of levonorgestrel 0.6-3.1%, although both are less effective when given as an advance supply; in addition, they “have an excellent safety profile, and no deaths or serious complications have been causally linked” to their use).
Donnez J, Hudecek R, Donnez O, Matule D, Arhendt HJ, Zatik J, Kasilovskiene Z, et al. (2015). Efficacy and safety of repeated use of ulipristal acetate in uterine fibroids. Fertil Steril. (Among 451 patients with symptomatic uterine fibroids treated with two 12-week courses of ulipristal [5 vs 10 mg daily], more than 80% had control of bleeding, and “laboratory results did not reveal any safety signals, and no patients discontinued treatment due to test abnormalities”).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, no cases were attributed to emergency contraception regimens).
Festin MP, Bahamondes L, Nguyen TM, Habib N, Thamkhantho M, Singh K, Gosavi A, et al. (2016). A prospective, open-label, single arm, multicentre study to evaluate efficacy, safety and acceptability of pericoital oral contraception using levonorgestrel 1.5 mg. Hum Reprod. (Among 330 women at risk of pregnancy given levonorgestrel tablets [1.5 mg] to use within 24 hours of intercourse, the pregnancy rate was 7.5 per 100 years of use and there were 3 serious adverse events [choledocholithiasis, anemia, and rupture of a corpus luteum cyst]; no mention of ALT elevations or hepatotoxicity).
Fauser BC, Donnez J, Bouchard P, Barlow DH, Vázquez F, Arriagada P, Skouby SO, et al. (2017). Safety after extended repeated use of ulipristal acetate for uterine fibroids. PLoS One. (Among 64 women with uterine fibroids treated with 1 to 8 three-month courses of ulipristal [10 mg daily], there were no changes in mean ALT or AST levels or in the “number of laboratory results falling outside of the normal range”).
Rabe T, Saenger N, Ebert AD, Roemer T, Tinneberg HR, De Wilde RL, Wallwiener M. (2018). Selective progesterone receptor modulators for the medical treatment of uterine fibroids with a focus on ulipristal acetate. Biomed Res Int. (Review of the efficacy and safety of ulipristal as therapy of uterine fibroids).
Donnez J. (2018). Liver injury and ulipristal acetate: an overstated tragedy?. Fertil Steril. (Brief summary of the results of liver test monitoring in the preregistration trials of ulipristal which showed no signal for potential hepatotoxicity).
(2018). Ulipristal acetate (Esmya): restrictions on use. Drug Ther Bull. (Summary of a European Union wide review of ulipristal that was initiated after receipt of 8 reports of severe liver injury among an estimated 750,000 women treated with the agent for uterine fibroids, which resulted in recommendations to restrict use of ulipristal [to women with normal liver tests and who have refractory, moderate-to-severe, symptomatic fibroids] and require monitoring of liver tests before, during and after each course of therapy).
Donnez J, Arriagada P, Marciniak M, Larrey D. (2018). Liver safety parameters ofulipristal acetate for the treatment of uterine fibroids: a comprehensive review of the clinical development program. Expert Opin Drug Saf. (Detailed analysis of the changes in serum ALT, AST, Alk P and bilirubin levels in the preregistration trials of ulipristal during which there were no elevations in ALT above 3 times ULN among 422 women who received 5 mg daily and only 7 of 631 who received 10 mg daily, and no instance of clinically apparent liver injury at any dosage).
Donnez J, Courtoy GE, Dolmans MM. (2019). Fibroid management in premenopausal women. Climacteric. (Review of clinical features and management of uterine fibroids in premenopausal women mentions that ulipristal “is safe, provides fast control of bleedings, and causes sustained fibroid volume reduction in the vast majority of cases”).
Del Forno S, Degli Esposti E, Salucci P, Leonardi D, Iodice R, Arena A, Raimondo D, et al. (2020). Liver function, tolerability and satisfaction during treatment with ulipristal acetate in women with fibroids: a single center experience. Gynecol Endocrinol. (Among 162 women treated with at least one 3-month course of ulipristal [5 mg daily] for uterine fibroids, “no cases of increased serum AST or ALT levels were detected”).
Meunier L, Meszaros M, Pageaux GP, Delay JM, Herrero A, Pinzani V, Dominique HB. Acute liver failure requiring transplantation caused by ulipristal acetate. Clin Res Hepatol Gastroenterol 2020: S2210-7401(20)30041-3. (58 year old woman with uterine fibroids developed fatigue 2 months after starting ulipristal followed by jaundice a week after stopping [bilirubin 25.5 mg/dL, ALT 1652 U/L, GGT 252 U/L, INR 2.5], with progressive hepatic failure leading to urgent liver transplantation; publication includes a table summarizing clinical features of 3 other cases of acute liver failure and liver transplantation in women arising 1-6 months after starting ulipristal for uterine fibroids).

## OTHER REFERENCE LINKS

1 Recent References on Emergency Contraceptive Agents: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Emergency+Contraceptive+Agents/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Levonorgestrel: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Levonorgestrel)
3 Trials on Ulipristal Acetate: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ulipristal)